# Moxidectin

## OVERVIEW

### Introduction

Moxidectin is a macrocyclic lactone anthelmintic drug given as a single oral dose for the treatment of onchocerciasis (river blindness). Moxidectin administration can be followed by transient increases in serum bilirubin and aminotransferase levels as a part of a generalized inflammatory reaction to the dying microfilariae of the parasitic worm, but the drug has not been linked to cases of clinically apparent liver injury.

### Background

Moxidectin (mox i dek’ tin) is a semisynthetic macrocyclic lactone originally developed for veterinary use against helminth and arthropod parasites in livestock and pets. Subsequent testing showed that it had potent activity against the microfilariae of Onchocerca volvulus, the parasite that causes onchocerciasis (river blindness). More than 99% of infected persons live in sub-Sahara Africa and Yemen, with rare cases found in the Amazon region of South America. Onchocerciasis is transmitted to humans by bites of the infected blackfly which lives and breeds in and along rivers. The adult worms produce microfilariae that migrate to skin and eye, where they cause inflammatory reactions that can result in skin disease, visual impairment, and blindness. Moxidectin causes paralysis and death of the microfilariae but does not kill the adult worm and thus does not eradicate infection. The reduction in microfilariae burden, however, is associated with lessening of inflammatory damage and symptoms. In a large, controlled trial, moxidectin was found to be more effective than ivermectin in reducing microfilariae burden and increasing rates of their undetectability at 1 month [83% vs 43%] and 12 months [46% vs 5%]. Moxidectin was approved for human use in the United States in 2018, initially for adults and children aged 12 years and older and later for younger children at a lower dosage based upon body weight. Moxidectin is available in tablets of 2 mg and the recommended regimen in adults is a single oral dose of 8 mg. Side effects are frequent but largely due to the “Mazzotti reaction” caused by the inflammatory response to dying microfilariae. The reaction occurs in more than 95% of patients, arising within days to a few weeks after administration. Manifestations can include pruritus, musculoskeletal pain, headache, rash, fever, chills, eosinophilia, tachycardia, orthostatic hypotension, and lymph node pain. Severe adverse reactions can include worsening eye involvement and symptomatic hypotension. In trials of moxidectin in other conditions, adverse event rates are low and similar to those with placebo or with comparator drug treatment.

### Hepatotoxicity

In the large, controlled trial of moxidectin vs ivermectin in onchocerciasis, transient serum aminotransferase elevations were found in 22% of moxidectin- and 21% of ivermectin-treated participants which were above 3 times ULN in 1.2% vs 1.6%. Bilirubin levels were also frequently elevated (9.9% vs 9.5%) but were transient resolving in all patients. Thus, the liver test abnormalities were invariably transient, mild to moderate in severity, and appeared to be part of the Mazzotti reaction, resolving within days or weeks of onset. No patient developed what could be considered clinically apparent liver injury. Since approval of moxidectin as therapy of onchocerciasis in humans, there have been no reports of liver injury with symptoms or jaundice associated with its use. There have also been no reports of liver injury with use of moxidectin in other human parasitic infections [such as Strongyloides stercoralis] where liver test abnormalities were no more frequent with moxidectin than with placebo.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why moxidectin has little or no hepatotoxicity is likely due to its minimal hepatic metabolism, being eliminated largely unchanged in feces with a slow terminal half-life of 20 to 35 days. The mild-to-moderate elevations in serum aminotransferase levels and bilirubin after therapy are likely due to the inflammatory responses to dying microfilariae which are more frequent and more severe with moxidectin compared to ivermectin probably because of the higher rate of microfilariae killing.

### Outcome and Management

Clinically apparent liver injury from moxidectin has not been described and there is no recommendation for monitoring liver tests with therapy. An important issue is that moxidectin does not eradicate the adult worms of Onchocerca volvulus, and repeated single, oral doses of moxidectin may be necessary because slow re-accumulation of microfilaria can occur starting 6 or more months after successful treatment. The efficacy, safety, and tolerance of repeated administration of moxidectin have not been shown.

There is no information to suggest cross-sensitivity to liver injury among macrocyclic lactones (e.g., ivermectin). Ivermectin, however, has extensive hepatic metabolism.

Drug Class: Antiinfective Agents; Anthelmintics

Other Drugs in the Subclass: Ivermectin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Moxidectin – Generic

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Moxidectin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Moxidectin | 113507-06-5 | C37H53NO8 | SID: 388728661

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2026

Abbreviations: ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of moxidectin).
Keiser J, McCarthy J, Hotez P. Chemotherapy of helminth Infections. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-9. (Textbook of pharmacology and therapeutics, the 16-membered macrocyclic lactones have been used to treat a broad spectrum of infections caused by parasitic nematodes and arthropods).
CDC website: https://www.cdc.gov/dpdx/onchocerciasis/index.html (CDC website with description of the life cycle of Onchocerca volvulus, geographic distribution, and information on the clinical features, diagnosis, management, and treatment of onchocerciasis).
Drugs@FDA. 2018
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210867Orig1s000ChemR.pdf (FDA website with product label and integrated review of efficacy and safety of moxidectin based upon data in support of its approval as therapy of onchocerciasis, mentions that in the large pre-registration controlled trial comparing moxidectin to ivermectin in 1472 patients, serious adverse event rates were 6.1% vs 5.9%, bilirubin elevations arose in 9.9% vs 9.5%, ALT elevations in 21.2% vs 20.6% which were above 3 times ULN in 1.2% vs 1.6% but these abnormalities arose in the first few weeks after therapy in conjunction with Mazzotti reactions that occurred in 99% vs 95% of patients, and the liver test abnormalities were interpreted as part of the inflammatory reaction and not directly due to the anthelmintics).
Cotreau MM, Warren S, Ryan JL, Fleckenstein L, Vanapalli SR, Brown KR, Rock D, et al. The antiparasitic moxidectin: safety, tolerability, and pharmacokinetics in humans. J Clin Pharmacol. 2003;43:1108-15. (Among 36 healthy male volunteers given a single oral dose of moxidectin [3, 9, 18 or 36 mg] or placebo, moxidectin was “generally safe and well tolerated” but CNS toxicity [headache, somnolence, dizziness] was seen with the highest doses; elimination half-life was long [20-35 days]; no mention of ALT elevations or hepatotoxicity). 14517193
Awadzi K, Opoku NO, Attah SK, Lazdins-Helds J, Kuesel AC. A randomized, single-ascending-dose, ivermectin-controlled, double-blind study of moxidectin in Onchocerca volvulus infection. PLoS Negl Trop Dis. 2014;8:e2953. (Among 172 Ghanian adults with onchocerciasis who received a single oral dose of moxidectin [2, 4 or 8 mg] or ivermectin, 97% to 100% had a Mazzotti reaction but symptoms were more frequent with the 8 mg moxidectin dose than with ivermectin such as pruritus [87% vs 56%], rash [63% vs 41%], and orthostatic hypotension [61% vs 27%], but all symptoms resolved without therapy, and in follow up, reduction in microfilariae density was greater with moxidectin). 24968000
Opoku NO, Bakajika DK, Kanza EM, Howard H, Mambandu GL, Nyathirombo A, Nigo MM, et al. Single dose moxidectin versus ivermectin for Onchocerca volvulus infection in Ghana, Liberia, and the Democratic Republic of the Congo: a randomised, controlled, double-blind phase 3 trial. Lancet. 2018;392(10154):1207-1216. (Among 1420 patients with onchocerciasis who received a single oral dose of moxidectin [8 mg] or ivermectin, microfilariae density at 12 months was lower with moxidectin [0.6 vs 4.5 microfilariae/mg of skin], Mazzotti reactions arose in 99% vs 97% including ocular reactions in 12% vs 10%; no mention of ALT elevations or hepatotoxicity). 29361335
Hofmann D, Sayasone S, Sengngam K, Chongvilay B, Hattendorf J, Keiser J. Efficacy and safety of ascending doses of moxidectin against Strongyloides stercoralis infections in adults: a randomised, parallel-group, single-blinded, placebo-controlled, dose-ranging, phase 2a trial. Lancet Infect Dis. 2021;21:1151-1160. (Among 223 adults with Strongyloides stercoralis infection treated with one of 6 single oral doses of moxidectin [2 to 12 mg] vs placebo, the cure rates were 75% to 88% vs 14%, and therapy was “well tolerated”, adverse event rates were similar, and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 33798487
Sprecher VP, Hofmann D, Savathdy V, Xayavong P, Norkhankhame C, Huy R, Khieu V, et al. Efficacy and safety of moxidectin compared with ivermectin against Strongyloides stercoralis infection in adults in Laos and Cambodia: a randomised, double-blind, non-inferiority, phase 2b/3 trial. Lancet Infect Dis. 2024;24:196-205. (Among 726 adults with Strongyloides stercoralis infection treated with a single oral dose of moxidectin [8 mg] vs ivermectin, cure rates were 94% vs 96%, and adverse event rates were similar in the two groups [abdominal pain in 9% vs 9% and headache in 7% vs 8%] and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 37949090

## OTHER REFERENCE LINKS

1. Recent References on Moxidectin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Moxidectin%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Moxidectin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Moxidectin)